# Attention Deficit/Hyperactivity Disorder (ADHD) Agents

## OVERVIEW

### Introduction

Attention deficit/hyperactivity disorder (ADHD) is neurodevelopment condition marked by variable degrees of inattention, inability to concentrate or focus, impulsivity and hyperactivity that are inconsistent with developmental levels and that impair daily life. ADHD is the most common neurodevelopment disorder of children and persists into adulthood in at least 20% of cases. Approximately 9% of children in the United States are affected by ADHD and its incidence appears to be rising. ADHD has major effects on learning and academic achievement as well as social interactions and occupational success.

Pharmacologic therapies can alleviate many of the symptoms of ADHD, but they are not always well tolerated. Currently approved drugs for ADHD are separated into those that are neurostimulatory (amphetamines and methylphenidate) versus nonstimulatory (clonidine, guanfacine, atomoxetine, and viloxazine). Amphetamines used to treat ADHD include miscellaneous specific forms such as dextroamphetamine and lisdexamfetamine as well as mixtures of amphetamines (Adderall and other generics). Methylphenidate is perhaps the most commonly used agent in treatment of ADHD and is available in short-, immediate-, and long-acting formulations generically and under the brand name Ritalin. Both amphetamines and methylphenidate are schedule II controlled substances, indicating that they have a high potential for abuse but a recognized medical usefulness. Nonstimulatory agents for ADHD are not controlled substances and do not have a potential for abuse. Guanfacine and clonidine are alpha-2 adrenergic agonists and were originally approved for treatment of hypertension and were later repurposed as therapy for ADHD. Atomoxetine and viloxazine are selective norepinephrine reuptake inhibitors both of which have also been used to treat depression, although neither is approved for this indication in the United States.

Most drugs used to treat ADHD have no or minimal hepatotoxicity when given in therapeutic doses. The amphetamines and methylphenidate can cause liver injury when given in high doses or as an overdose. Methylphenidate and atomoxetine have also been implicated in rare cases of idiosyncratic liver injury with therapeutic doses. In contrast, guanfacine and clonidine have not been linked to cases of clinically apparent liver injury despite years of clinical experience with their use. Finally, viloxazine, a selective norepinephrine reuptake inhibitor and modulator of serotonin receptor activity has recently been approved for ADHD and has not been linked to clinically apparent instances of acute liver injury.

An important factor in management of ADHD is that behavioral therapies are recommended as the first line of therapy, particularly for children and adolescents, and pharmacologic treatment should complement rather than replace behavioral therapy. These interventions include parent training and classroom interventions for children and adolescents. These behavioral therapies may allow for clinical improvements with lower doses of medications for ADHD.

The medications currently approved as therapy for ADHD are each discussed in detail in the specific chapters in LiverTox, links to which are provided below. Each chapter has an annotated bibliography of references to the specific agents, while general references are provided in the Annotated Bibliography given with this Overview.

Stimulants:

Amphetamines

Methylphenidate

Nonstimulants:

Atomoxetine

Clonidine

Guanfacine

Viloxazine

## ANNOTATED BIBLIOGRAPHY

References updated: 25 August 2021

Abbreviations: ADHD, attention deficit/hyperactivity disorder; SNRI, selective norepinephrine reuptake inhibitor.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 mentions cases of acute hepatitis attributed to abuse of amphetamines; at least 3 instances of acute liver injury attributed to methylphenidate; states that “viloxazine has been mentioned as a cause of jaundice but there are no specific descriptions”; no mention of clonidine, guanfacine or atomoxetine).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of antidepressants and drugs of abuse mentions that methylphenidate has been implicated in hepatocellular injury and that amphetamine and its derivatives can cause acute liver injury, most likely due to hypothermia).
Westfall TC, Macarthur H, Westfall DP. Adrenergic agonists and antagonists. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 191-224. (Textbook of pharmacology and therapeutics).
Lim JR, Faught PR, Chalasani NP, Molleston JP. (2006). Severe liver injury after initiating therapy with atomoxetine in two children. J Pediatr. (Two cases: 12 year old girl developed jaundice 3 weeks after restarting atomoxetine [bilirubin 9.1 mg/dL, ALT 3264 U/L, Alk P 231 U/L, ANA 1:160, IgG 769 mg/dL], resolving in 8 weeks of stopping; 11 year old girl developed fatigue 3 months after starting atomoxetine [bilirubin 0.5 mg/dL, ALT 675 U/L, Alk P 96 U/L, ANA 1:320, IgG 7,390 mg/dL] and biopsy suggesting chronic hepatitis, hepatitis improving within a few weeks of starting prednisone).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including one attributed to cocaine and one to ecstasy [MDMA] but none to methylphenidate, guanfacine, clonidine or atomoxetine).
Vanga RR, Bal B, Olden KW. (2013). Adderall induced acute liver injury: a rare case and review of the literature. Case Rep Gastrointest Med. (55 year old woman developed acute liver injury with hepatic encephalopathy 9 months after starting amphetamine for ADHD and 5 days after increasing the dose [bilirubin 1.8 rising to 3.3 mg/dL, ALT ~5500 U/L], resolving rapidly within 2 weeks of stopping).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, of which none were attributed to amphetamines, methylphenidate or other drug used for treatment of ADHD).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to amphetamines or other drugs used for treatment of ADHD).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 3 cases were attributed to atomoxetine and one to methylphenidate, but none to cocaine, ecstasy, guanfacine, clonidine or viloxazine).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, two agents used for ADHD were among the top 40 causes; methylphenidate [11th, 96 cases] and atomoxetine [14th, 64 cases]).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (Among 313 cases of drug induced liver injury seen between 1997 and 2008 at a large hospital in Bangalore, India, one case was attributed to atomoxetine, none to methylphenidate).
Drugs for ADHD. (2020). Med Lett Drugs Ther. (Concise review of mechanism of action, clinical efficacy, toxicity and costs of drugs for ADHD mentions that atomoxetine can rarely cause acute hepatitis, but does not mention ALT elevations or hepatotoxicity in discussion of other drugs for ADHD including the amphetamines, methylphenidate, guanfacine and clonidine).
Cortese S. (2020). Pharmacologic treatment of attention deficit-hyperactivity disorder. N Engl J Med. (Review of the pharmacological therapy of ADHD with discussion of amphetamines, methylphenidate, atomoxetine, guanfacine and clonidine; no mention of ALT elevations during therapy or hepatotoxicity).
Viloxazine ER. (2021). (Qelbree) for ADHD. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy, safety and costs of viloxazine shortly after its approval for use in the US for ADHD, mentions side effects of somnolence, fatigue, insomnia, anorexia, irritability, nausea, vomiting, headache, weight loss, suicidal ideation and behavior and embryo-fetal toxicity; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on ADHD: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=ADHD+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Clinical Trials in ADHD: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=ADHD)